# Selumetinib

## OVERVIEW

### Introduction

Selumetinib is an oral, small molecule inhibitor of the mitogen activated protein kinase 1 and 2 (MEK1/2) that is used to treat symptomatic, refractory fibromas in neurofibromatosis type 1. Selumetinib is associated with transient and usually mild elevations in serum aminotransferase levels during therapy, but has not been linked to cases of clinically apparent acute liver injury.

### Background

Selumetinib (sel" ue me’ ti nib) is an orally available, specific inhibitor of mitogen activated protein kinase 1 and 2 (MEK1/2) and is used to treat neurofibromatosis. Neurofibromatosis type 1 is marked by a mutation in the neurofibromin, a tumor suppressor gene which is a negative regulator of the RAS/MAPK signaling pathway. The mutant neurofibromin causes dysregulation of the RAF/MEK/ERK pathway and promotes tumor growth. In open label trials, selumetinib was found to improve symptoms and result in decrease in volume and distribution of neurofibromas in children with neurofibromatosis type 1. While partial responses occurred in more than half of patients, none had a complete response and resolution of all neurofibromas. Selumetinib was approved for use in neurofibromatosis in the United States in 2020. It is also being evaluated in other forms of cancer, such as melanoma, gliomas, and non-small cell lung cancer in which MEK1/2 is overexpressed. Current indications are for children above the age of 2 and adults with neurofibromatosis type 1 with symptomatic, inoperable plexiform neurofibromas. It is available in capsules of 10 and 25 mg under the brand name Koselugo. The usual recommended dose 25 mg/m^2^ twice daily. Side effects are very common and include rash, diarrhea, nausea, vomiting, abdominal pain, fatigue, fever, stomatitis, headache, paronychia and pruritus. Severe adverse events occur in approximately 24% of patients and lead to discontinuation in 12%. Severe adverse events include cardiomyopathy, ocular abnormalities with blurred and decreased vision, severe diarrhea and dehydration, severe skin rash, marked CPK elevations and rarely rhabdomyolysis, and embryo-fetal toxicity. Both cardiac and ophthalmologic monitoring is recommended.

### Hepatotoxicity

In the prelicensure clinical trials conducted in children and adults with neurofibromatosis, serum aminotransferase elevations occurred in 35% of treated subject but rose to above 5 times the upper limit of normal (ULN) in only 4%. However, there were no liver related serious adverse events and no patient had a concurrent elevation in serum aminotransferase and bilirubin levels. The ALT elevations were typically mild and transient and usually resolved even without dose adjustment. There were no instances of clinically apparent liver injury attributed to selumetinib. Since approval and more wide scale availability of selumetinib, there have been no published reports of clinically apparent drug induced liver injury associated with its use in neurofibromatosis, although clinical experience with the drug, particularly with long term therapy, has been limited. However, in studies of experimental therapy with somewhat higher doses of selumetinib in patients with advanced, refractory cancers, liver test abnormalities were common and sometimes graded as severe (ALT above 20 times ULN) and requiring drug discontinuation. Thus, in patients with neurofibromatosis and use of recommended doses of selumetinib, clinically apparent liver injury is rare if it occurs at all. At higher doses, however, selumetinib has been associated with a very high rate of serum enzyme elevations, many of which were in the range suggestive of severe injury.

Likelihood score: E* (suspected but unproven rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations during selumetinib therapy are not known. Selumetinib is metabolized in the liver largely through the cytochrome P450 pathway and specifically by CYP 3A4, and liver injury may be related to production of a toxic or immunogenic intermediate. Because it is a substrate for CYP 3A4, selumetinib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity.

### Outcome and Management

Monitoring of laboratory tests (particularly CPK) is recommended for patients treated with selumetinib. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation. There are no data to suggest a cross reactivity in risk for hepatic injury between selumetinib and other kinase inhibitors.

Drug Class: Genetic Disorder Agents, Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Selumetinib – Koselugo®

DRUG CLASS

Genetic Disorder Agents, Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Selumetinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Selumetinib | 606143-52-6 | C17-H15-Br-Cl-F-N4-O3

## ANNOTATED BIBLIOGRAPHY

References updated: January 21, 2021

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as selumetinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not selumetinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics; selumetinib is not discussed specifically).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213756Orig1s000MultidisciplineR.pdf (FDA website with medical review of efficacy and safety of selumetinib which formed the basis of its approval for use in neurofibromatosis, mentions that in registration trials in adults and children with neurofibromatosis there were no liver related serious adverse events, and although ALT elevations arose in 35% of children, none were associated with symptoms or jaundice).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; selumetinib is not discussed).
Spraggs CF, Xu CF, Hunt CM. (2013). Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; selumetinib is not mentioned).
Dombi E, Baldwin A, Marcus LJ, Fisher MJ, Weiss B, Kim A, Whitcomb P, et al. (2016). Activity of selumetinib in neurofibromatosis type 1-related plexiform neurofibromas. N Engl J Med. (Among 24 children with neurofibromatosis and symptomatic plexiform neurofibromas treated in 28 day cycles of 3 doses of selumetinib [20, 25 or 30 mg/m^2^ twice daily] for a median of 30 cycles, tumor volume decreased in all subjects and dose limiting adverse events included CPK elevations, rash, cellulitis, mucositis and decline in ventricular ejection fraction; 11 episodes of ALT elevation arose but all were transient and mild [less than 3 times ULN]).
Holkova B, Zingone A, Kmieciak M, Bose P, Badros AZ, Voorhees PM, Baz R, et al. (2016). A phase II trial of AZD6244 (selumetinib, ARRY-142886), an oral MEK1/2 inhibitor, in relapsed/refractory multiple myeloma. Clin Cancer Res. (Among 36 patients with refractory or relapsed multiple myeloma treated with selumetinib [75 mg twice daily in 28 day cycles], only 2 [6%] had an objective response and adverse events were common, mostly hematologic, 2 patients developing ALT elevations, one of which was above 20 times ULN).
Alves Júnior SF, Zanetti G, Alves de Melo AS, Souza AS, Souza LS, de Souza Portes Meirelles G, Irion KL, et al. (2019). Neurofibromatosis type 1: State-of-the-art review with emphasis on pulmonary involvement. Respir Med. (Review of the pathogenesis, epidemiology, clinical features and natural history of neurofibromatosis type 1 [von Recklinghausen disease], an autosomal dominant condition affecting 1:3000 persons that typically presents in childhood with café au lait spots, multiple neurofibromas, pigmented hamartomas, in the iris, seizures, bone and eye disease and, in adulthood, diffuse lung disease).
Fangusaro J, Onar-Thomas A, Young Poussaint T, Wu S, Ligon AH, Lindeman N, Banerjee A, et al. (2019). Selumetinib in paediatric patients with BRAF-aberrant or neurofibromatosis type 1-associated recurrent, refractory, or progressive low-grade glioma: a multicentre, phase 2 trial. Lancet Oncol. (Among 50 children with low grade gliomas treated with selumetinib [25 mg/m^2^ twice daily], partial responses occurred in 35-40% and adverse events were frequent, ALT elevations arising in 21 [42%], but all but one was mild [less than 3 times ULN] and none were associated with symptoms or jaundice or required drug discontinuation).
Gross AM, Wolters PL, Dombi E, Baldwin A, Whitcomb P, Fisher MJ, Weiss B, et al. (2020). Selumetinib in children with inoperable plexiform neurofibromas. N Engl J Med. (Among 50 children with neurofibromatosis and symptomatic plexiform neurofibromas treated with selumetinib in 28 day cycles, tumor volume decreased in 34 [68%] which was durable in 28 [56%] and accompanied by improvements in pain scores, quality of life and strength; adverse events were common and led to discontinuation in 10%; ALT elevations arose in 14 [28%], but only 1 [2%] was above 3 times ULN).
Markham A, Keam SJ. (2020). Selumetinib: first approval. Drugs. (Review of the history of development, pharmacology, mechanism of action, clinical efficacy and safety of selumetinib shortly after its initial approval as therapy of neurofibromatosis type 1 in the US; mentions occurrence of ALT elevations in 35% of subjects, but does not mention episodes of clinically apparent hepatotoxicity).
Kenney C, Kunst T, Webb S, Christina D, Arrowood C, Steinberg SM, Mettu NB, et al. (2021). Phase II study of selumetinib, an orally active inhibitor of MEK1 and MEK2 kinases, in KRAS-G12R-mutant pancreatic ductal adenocarcinoma. Invest New Drugs. (Among 8 patients with advanced pancreatic cancer and KRAS variants treated with selumetinib [75 mg twice daily], none had even a partial objective response and side effects were common, all 8 developed ALT elevations which were above 20 times ULN in 2 requiring dose discontinuation or reduction, one subject also developed jaundice; few details given).

## OTHER REFERENCE LINKS

1 Recent References on Selumetinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Selumetinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Selumetinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Selumetinib)